# Brincidofovir

## OVERVIEW

### Introduction

Brincidofovir is an orally available antiviral agent with activity against smallpox and several other DNA viruses that is currently approved for use against smallpox virus (variola) infection in humans and has been given emergency use authorization for treatment of monkeypox (now renamed “mpox”) infection. Brincidofovir therapy has been linked to a low rate of serum aminotransferase elevations during therapy, but has not been implicated in instances of clinically apparent liver injury.

### Background

Mpox

inhibits the orthopoxvirus DNA polymerase, which is required for its replication and is highly conserved among orthopoxviruses. The lipid conjugate consists of a lipophosphatidylcholine that allows intestinal absorption by lipid uptake pathways. Inside cells the lipid ester linkage is cleaved releasing cidofovir, which is phosphorylated by intracellular enzymes to its active antiviral moiety, cidofovir diphosphate. Brincidofovir has a similar spectrum of activity as cidofovir which is an approved therapy for cytomegalovirus (CMV) retinitis in patients with HIV infection. Cidofovir, however, requires parenteral administration and has major, dose limiting adverse effects of renal injury and neutropenia. In contrast, brincidofovir is orally available and has a broad and potent antiviral activity that allows for short term therapy. It also appears to be better tolerated than cidofovir. Brincidofovir was approved as therapy of smallpox virus infection in 2021 based the Animal Rule using efficacy trials conducted in animal models of smallpox and safety studies conducted in human volunteers and in trials of brincidofovir for other viral infections (adenovirus, Ebola, cytomegalovirus [CMV]). Brincidofovir is available in tablets of 100 mg and as an oral solution in vials of 10 mg/mL for pediatric and enteral administration. The recommended dose in adults is 200 mg orally once weekly for two doses (day 1 and day 8). The dose in children is based upon body weight. Longer term therapy is not recommended because of increase in adverse events and occurrence of excess mortality with prolonged brincidofovir therapy in one preregistration controlled trial. Currently, brincidofovir is being actively evaluated for efficacy and safety in treating patients with mpox and vaccinia infections, and is used off label as prevention or therapy of adenovirus and cytomegalovirus infection after hematopoietic stem cell transplantation (HSCT). Brincidofovir appears to be generally well tolerated with major adverse events being gastrointestinal intolerance due to diarrhea, dyspepsia, nausea and vomiting. Other adverse events include headache, myalgia, rash, pruritus and serum aminotransferase elevations. The total clinical experience with brincidofovir has been limited and its safety is not fully defined. It demonstrates embryo-fetal toxicity in animals and is contraindicated in women of child bearing potential not on effective contraception.

### Hepatotoxicity

In preregistration clinical trials of brincidofovir as prevention of cytomegalovirus and adenovirus infection in adults and children after hematopoietic stem cell transplantation (HSCT), serum aminotransferase elevations were more frequent with brincidofovir (22%) than placebo (16%) treatment, the usual rate of hepatic enzyme elevations being high after HSCT. ALT elevations above 5 times the upper limit of normal (ULN) arose in 1.8% vs 1.4% , and one of 269 brincidofovir recipients discontinued therapy because of ALT elevations above 10 times ULN. The ALT and AST elevations arose early as brincidofovir was given only 2 or 3 times, on days 1 and 8 and in some trials day 21 of treatment. In the same trials mild-to-moderate elevations in serum bilirubin arose in 6.5% of those on brincidofovir vs 5.9% of placebo recipients, again reflecting the high rate of bilirubin elevations in patients after HSCT. In small studies in healthy human volunteers abnormalities of liver tests were not observed. Since approval of brincidofovir, there have been no instances of smallpox infection that qualified for its use. However, the emergence of mpox infection shortly after its approval has led to its use for this non-approved indication. Aminotransferase elevations were frequent in the mpox virus infected subjects treated with brincidofovir but were invariably asymptomatic, transient and without symptoms or concurrent bilirubin elevations. Thus, the total clinical experience with use of brincidofovir is limited. While transient serum aminotransferase elevations have been reported with its use, there have been no reports of clinically apparent liver injury linked to brincidofovir therapy.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The relative lack of serious adverse events and clinically apparent hepatic injury from brincidofovir may be due to its short duration of administration, being recommended for two doses only given one week apart. Whether longer term brincidofovir is also without serious hepatic adverse events remains to be seen. Brincidofovir is an inhibitor of several drug-metabolizing cytochrome P450 enzymes but has few clinically significant drug-drug interactions. Its metabolism, however, is affected by inhibitors of the organic anion transport protein (OATP) 1B1 and the concomitant use of such inhibitors (e.g., cyclosporine, clarithromycin, tenofovir and agents for chronic hepatitis C) increases plasma levels of brincidofovir and should be avoided.

### Outcome and Management

The product label for brincidofovir recommends screening for liver test abnormalities before starting therapy and repeating tests as clinically indicated. The mild ALT elevations associated with brincidofovir therapy are usually self-limited and do not require dose modification. Because brincidofovir is usually given only in two doses one week apart, monitoring of liver tests is generally done before the second dose (day 8). In this situation, the second dose should be held if symptoms of hepatitis arise or if serum aminotransferases are known to rise and persist above 10 times ULN. Abnormalities in liver tests usually resolve rapidly when brincidofovir is stopped. Clinically apparent liver injury with jaundice attributable to brincidofovir has not been described but the overall experience with use of this medication has been limited.

Drug Class: Antiviral Agents

Other Drugs in the Subclass: Nucleoside Analogues, Tecovirimat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brincidofovir – Tembexa®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brincidofovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Brincidofovir | 444805-28-1 | C27-H52-N3-O7-P

## ANNOTATED BIBLIOGRAPHY

References updated: 18 October 2022

Abbreviations used: CMV, cytomegalovirus; HSCT, hematopoietic stem cell transplantation.

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214460Orig1s000,%20214461Orig1s000TOC.cfm (FDA website is medical review of the application for licensure of brincidofovir as therapy of smallpox infection in humans based upon proof of efficacy in animal models with safety data based upon treatment of healthy volunteers mentions that the common adverse events are largely gastrointestinal (diarrhea, nausea, vomiting), but also hepatic with slightly higher rates of ALT, AST and bilirubin elevations in brincidofovir treated subjects compared to controls; ALT elevations arose in 22% of 392 subjects on brincidofovir vs 16% of 208 placebo treated subjects and were above 5 times ULN in 1.8% vs 1.4% and none in association with elevations in bilirubin or clinically apparent hepatitis).
Quenelle DC, Prichard MN, Keith KA, Hruby DE, Jordan R, Painter GR, Robertson A, et al. (2007). Synergistic efficacy of the combination of ST-246 with CMX001 against orthopoxviruses. Antimicrob Agents Chemother. (Tecovirimat [ST-146] and brincidofovir [CMX001] showed synergy in antiviral activity against cowpox and vaccinia virus in cell culture as well in reducing mortality in a mouse model of cowpox infection; results that are compatible with the different viral targets of the two agents).
Parker S, Touchette E, Oberle C, Almond M, Robertson A, Trost LC, Lampert B, et al. (2008). Efficacy of therapeutic intervention with an oral ether-lipid analogue of cidofovir (CMX001) in a lethal mousepox model. Antiviral Res. (Brincidofovir provided protection against fatal mousepox virus infection equal to that of cidofovir even when given 1-5 days after intranasal exposure).
Florescu DF, Pergam SA, Neely MN, Qiu F, Johnston C, Way S, Sande J, et al. (2012). Safety and efficacy of CMX001 as salvage therapy for severe adenovirus infections in immunocompromised patients. Biol Blood Marrow Transplant. (Among 13 immunodeficient or post-transplant patients with adenovirus infection resistant to intravenous cidofovir who were switched to oral brincidofovir [1-3 mg/kg/week], 9 had a virologic response, renal status was stable or improved and there were no serious or grade 3 or 4 adverse events attributed to the drug).
Painter W, Robertson A, Trost LC, Godkin S, Lampert B, Painter G. (2012). First pharmacokinetic and safety study in humans of the novel lipid antiviral conjugate CMX001, a broad-spectrum oral drug active against double-stranded DNA viruses. Antimicrob Agents Chemother. (In single and multiple dose [days 0, 6 and 12] studies of different doses of brincidofovir given to 108 healthy volunteers, the drug was well tolerated and “no clinically significant changes in blood chemistry, hematology, renal function, or intraocular pressure were observed”).
Dunning J, Kennedy SB, Antierens A, Whitehead J, Ciglenecki I, Carson G, Kanapathipillai R, et al. (2016). RAPIDE-BCV trial team. Experimental treatment of Ebola virus disease with brincidofovir. PLoS One. (None of the first 4 Liberian patients with acute Ebola virus disease enrolled in an open label trial of brincidofovir to be given on days 0, 3, 7, 10 and 14 survived for 14 days and the trial was discontinued).
Grimley MS, Chemaly RF, Englund JA, Kurtzberg J, Chittick G, Brundage TM, Bae A, et al. (2017). Brincidofovir for asymptomatic adenovirus viremia in pediatric and adult allogeneic hematopoietic cell transplant recipients: a randomized placebo-controlled phase II trial. Biol Blood Marrow Transplant. (Among 48 patients with asymptomatic adenovirus infection after hematopoietic stem cell transplant [HSCT] treated with brincidofovir [100 mg twice weekly or 200 mg once weekly] or placebo for 6-12 weeks, virologic failure occurred in similar proportions of those on brincidofovir vs placebo [30% vs 33%] while adverse events that were more frequent included diarrhea [47% vs 28%] and graft vs host disease [37% vs 17%], but ALT elevations above 5 times ULN arose in fewer [7% vs 22%]).
Hiwarkar P, Amrolia P, Sivaprakasam P, Lum SH, Doss H, O'Rafferty C, Petterson T, et al., United Kingdom Paediatric Bone Marrow Transplant Group. (2017). Brincidofovir is highly efficacious in controlling adenoviremia in pediatric recipients of hematopoietic cell transplant. Blood. (Among 333 children undergoing HCT in 7 transplant centers in the UK in 2015 and 2016, 47 developed adenovirus infection, with significant viral levels in 27 who were treated with cidofovir or brincidofovir or both after failure of the first, of whom major virologic responses occurred in 72% [12 of 16] given brincidofovir compared to only 9% [2 of 23] given cidofovir, and only 1 brincidofovir treated patients required early discontinuation, which was due to diarrhea and abdominal cramps; no mention of ALT levels or hepatotoxicity).
Chittick G, Morrison M, Brundage T, Nichols WG. (2017). Short-term clinical safety profile of brincidofovir: A favorable benefit-risk proposition in the treatment of smallpox. Antiviral Res. (In short term controlled trials in patients with various viral infections, elevations in serum ALT occurred in 8% [24 of 292] of those treated with brincidofovir in optimal recommended dose compared to 2% [5 of 208] of placebo controls but elevations were asymptomatic, transient and mild-to-moderate in severity).
Foster SA, Parker S, Lanier R. (2017). The role of brincidofovir in preparation for a potential smallpox outbreak. Viruses. (Commentary on the potential role of brincidofovir in response to bioterrorism with smallpox virus, describes its efficacy in animal models of smallpox [rabbitpox and mousepox] and the advantage of having two agents with activity against smallpox that are directed at different viral targets and exhibit no cross resistance if a genetically engineered smallpox virus was used).
Ramsay ID, Attwood C, Irish D, Griffiths PD, Kyriakou C, Lowe DM. (2017). Disseminated adenovirus infection after allogeneic stem cell transplant and the potential role of brincidofovir – Case series and 10 year experience of management in an adult transplant cohort. J Clin Virol. (Among 733 adults undergoing HSCT between 2005 and 2015 at a single UK referral center, 10 developed disseminated adenovirus infection of whom 3 died and 3 were treated with brincidofovir [50-100 mg twice weekly for 5-18 doses], all having a virologic response, but one dying despite decrease in viremia).
Marty FM, Winston DJ, Chemaly RF, Mullane KM, Shore TB, Papanicolaou GA, Chittick G, et al., SUPPRESS Trial Clinical Study Group. (2019). A randomized, double-blind, placebo-controlled phase 3 trial of oral brincidofovir for cytomegalovirus prophylaxis in allogeneic hematopoietic cell transplantation. Biol Blood Marrow Transplant. (Among 230 CMV-positive transplant recipients treated with placebo or varying dose regimens of brincidofovir after engraftment for 9-11 weeks, subsequent CMV events arose in 10% receiving the higher doses of brincidofovir vs 37% on placebo, while adverse events more frequent with the higher doses included nausea, vomiting, and diarrhea but not renal or bone marrow dysfunction; ALT levels above 3 times ULN arose in 15% on placebo vs 32-40% of higher doses of brincidofovir).
Londeree J, Winterberg PD, Garro R, George RP, Shin S, Liverman R, Serluco A, et al. (2020). Brincidofovir for the treatment of human adenovirus infection in pediatric solid organ transplant recipients: A case series. Pediatr Transplant. (Among 4 children who developed adenovirus disease after solid organ transplant treated with brincidofovir, all 4 became virus negative within 15-32 days of treatment but all also developed ALT elevations [peak 69 to 719 U/L], which resolved with resolution of viremia well before stopping therapy).
Ehlert K, Schulte JH, Kühl JS, Lang P, Eggert A, Voigt S. (2021). Efficacy of brincidofovir in pediatric stem cell transplant recipients with adenovirus infections. Pediatric Infect Dis Soc. (Among 8 children with resistant adenovirus infection after HSCT treated with 6 to 12 doses of brincidofovir, adenovirus was cleared in 6 but only 4 survived; ALT elevations and hepatic dysfunction occurred in 2 patients but were attributed to the adenovirus infection and graft vs host disease).
Chan-Tack K, Harrington P, Bensman T, Choi SY, Donaldson E, O'Rear J, McMillan D, et al. (2021). Benefit-risk assessment for brincidofovir for the treatment of smallpox: U.S. Food and Drug Administration's Evaluation. Antiviral Res. (Summary of the FDA evaluation of the efficacy and safety of brincidofovir in support of its approval as therapy of smallpox, which was based upon the Animal Rule that requires proof of efficacy in at least 2 appropriate animal models and safety analyses in healthy volunteers or patients with other viral infections; mentions that in pooled analyses on 392 patients who were treated with brincidofovir in the dose recommended for smallpox, elevations in ALT, AST and bilirubin were observed but there were no severe hepatic adverse events or instances of clinically apparent liver injury).
Perruccio K, Menconi M, Galaverna F, Pagliara D, Carraro F, Fagioli F, Calore E, et al., AIEOP Infectious Disease and Stem Cell Transplantation Working Parties. (2021). Safety and efficacy of brincidofovir for adenovirus infection in children receiving allogeneic stem cell transplantation: an AIEOP retrospective analyses. Bone Marrow Transplant. (Among 30 Italian children undergoing HSCT who developed 44 episodes of adenovirus infection between 2012 and 2019, 23 received cidofovir and 21 brincidofovir which demonstrated superior viral suppression and response rates with lesser toxicity and shorter courses of treatment; no mention of ALT elevations or hepatotoxicity).
Rao AK, Schulte J, Chen TH, Hughes CM, Davidson W, Neff JM, Markarian M, et al., July 2021 Monkeypox Response Team. (2022). Monkeypox in a traveler returning from Nigeria – Dallas, Texas, July 2021. MMWR Morb Mortal Wkly Rep. (Case report of a middle aged man who developed fever, fatigue, cough and rash during travel in Nigeria and who presented with an extensive pustula rash 4 days after return to the United States where a West African clade of mpox virus was identified from a swab of a lesion, this being the first imported case of mpox virus infection in the US; follow up found no secondary cases in contacts).
Adler H, Gould S, Hine P, Snell LB, Wong W, Houlihan CF, Osborne JC, et al. (2022). NHS England High Consequence Infectious Diseases (Airborne) Network. Clinical features and management of human monkeypox: a retrospective observational study in the UK. Lancet Infect Dis. (Among 7 patients diagnosed with mpox virus in the UK between 2018 and 2021, 3 were treated with brincidofovir [200 mg given as 3 weekly doses], all of whom developed ALT elevations [331, 550 and 127 U/L, without jaundice] and did not complete therapy, while 1 patient received tecovirimat [600 mg twice daily for 2 weeks], with rapid resolution of rash and clearance of virus; all patients ultimately recovered).
O'Shea J, Filardo TD, Morris SB, Weiser J, Petersen B, Brooks JT. (2022). Interim guidance for prevention and treatment of monkeypox in persons with HIV infection – United States, August 2022. MMWR Morb Mortal Wkly Rep. (Guidance for prevention and treatment of mpox infections in persons with HIV infection from the Centers for Disease Control and Prevention [CDC] in response to the multinational outbreak of mpox virus infections in May 2022; discussion of brincidofovir does not include mention of ALT elevations or hepatotoxicity).
Rizk JG, Lippi G, Henry BM, Forthal DN, Rizk Y. (2022). Prevention and treatment of monkeypox. Drugs. (Review of the prevention and treatment of mpox virus infection mentions 2 live virus vaccines against smallpox [JYNNEOS and ACAM2000] that are approximately 85% effective against mpox; and discusses 4 antiviral agents [tecovirimat, cidofovir, brincidofovir, and vaccinia immune globulin] which are not formally approved for use in mpox but can be obtained under an expanded access IND program; mentions that brincidofovir can cause serum aminotransferase and bilirubin elevations).
Siegrist EA, Sassine J. Antivirals with activity against monkeypox: a clinically oriented review. Clin Infect Dis. 2022 Jul 29:ciac622. Epub ahead of print. (Review of the efficacy and safety of three drugs with activity against mpox virus infection that are available in the US: cidofovir, brincidofovir and tecovirimat, mentions that brincidofovir has been associated with transient elevations in serum aminotransferase and bilirubin levels).
See KC. (2022). Vaccination for monkeypox virus infection in humans: a review of key considerations. Vaccines (Basel). (Review of the clinical features, epidemiology, prevention and treatment of mpox virus infection discusses tecovirimat, brincidofovir and vaccinia immunoglobulin; mentions that brincidofovir therapy is associated with ALT elevations and has the potential for carcinogenesis, while not mentioning adverse events attributed to tecovirimat or vaccinia immunoglobulin).
(2022). Prevention and treatment of monkeypox. Med Lett Drugs Ther. (Concise review on the global outbreak of mpox disease in 2022 that was associated with human-to-human transmission, most frequently in men who have sex with men, and a summary of prevention [vaccination with ACAM2000 or Jynneos, which are live vaccinia virus vaccines approved for prevention of smallpox], and treatment [two agents that are approved as therapy of smallpox which are available under an expanded access protocol for mpox]).

## OTHER REFERENCE LINKS

1 Recent References on Brincidofovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Brincidofovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Brincidofovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brincidofovir)